# Prucalopride

## OVERVIEW

### Introduction

Prucalopride is a serotonin type 4 (5-HT4) receptor agonist that has potent prokinetic activity and is used as therapy for chronic idiopathic constipation. Prucalopride has been associated with a minimal rate of transient serum enzyme elevations during therapy and has not been implicated in cases of clinically apparent liver injury with jaundice.

### Background

Prucalopride (proo kal' oh pride) is a highly selective serotonin type 4 (5-HT4) receptor agonist that increases the release of serotonin by the specialized enterochromaffin cells in the mucosa of the gut and stimulates intestinal peristalsis and tone. Serotonin (5-HT) is released in response to chemical and mechanical stimulation and acts through the type 4 receptors that are common in the intestinal mucosa to increase peristalsis and intestinal tone. 5-HT4 receptors are also found in the central nervous system, urinary bladder and atria of the heart, which may explain some of the adverse effects of 5-HT4 receptor agonists. Prucalopride was found to improve symptoms of bloating and gastric distension in patients with gastroparesis and to decrease symptoms of reflux in patients with GERD. Prucalopride was approved in the United States in 2018 for treatment of idiopathic chronic constipation. Prucalopride is available in tablets of 1 and 2 mg under the brand name Motegrity. The recommended dose in adults is 2 mg once daily with a lower dose recommended for patients with renal impairment (creatinine clearance less than 30 mL/min). Adverse events include headache, abdominal pain, nausea, diarrhea, abdominal bloating, dizziness, flatulence and fatigue. Uncommon but potentially severe adverse events include depression, suicidal ideation and behavior and hypersensitivity reactions. Two 5-HT4 receptor agonists were approved for treatment of chronic constipation in the past (cisapride in 1993, tegaserod in 2002), both of which were subsequently withdrawn from general use because of serious adverse events including cardiac arrhythmias and prolongation of the QTc interval. Prucalopride is a more highly selective 5HT4 receptor agonist and has not been linked to an increased rate of these cardiac adverse events.

### Hepatotoxicity

Prucalopride therapy was associated with a low rate of serum enzyme elevations during therapy (<1%) that was not different from that of placebo recipients. The elevations noted were mild and transient and did not required dose adjustment. In the many large clinical trials of prucalopride therapy in patients with chronic constipation, there were no reports of clinically apparent liver injury and since its approval there have been no published reports of liver injury attributed to prucalopride.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which prucalopride might cause liver injury is unknown. It is used in low total doses which may explain its relative lack of hepatotoxicity. Prucalopride is metabolized in the liver, largely via CYP 3A4 and is a substrate for P-glycoprotein. Prucalopride is susceptible to drug-drug interactions with agents that induce or inhibit CYP 3A4 or P-glycoprotein.

Drug Classes: Gastrointestinal Agents, Agents for Constipation, Irritable Bowel Syndrome Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Prucalopride – Motegrity®

DRUG CLASS

Gastrointestinal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Prucalopride)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Prucalopride | 179474-81-8 | C18-H26-Cl-N3-O3 | Prucalopride Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 25 April 2019

Zimmerman HJ. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 717-8. (Expert review of hepatotoxicity published in 1999; mentions that cisapride, a serotonin type 4 receptor agonist, was reported to lead to one case of liver injury [hepatocellular] during a decade of use).
Sharkey KA, McNaughton WK. Gastrointestinal motility and water flux, emesis, and biliary and pancreatic disease. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 921-44. (Textbook of pharmacology and therapeutics; the serotonin type 4 receptor agonists are used predominantly for treatment of diseases of intestinal motility and irritable bowel syndrome).
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2018/210166Orig1s000TOC.cfm (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions that review of 6 studies in more than 3000 treated patients did not raise clinical safety concerns and that there was no evidence of drug induced liver injury).
Camilleri M, Kerstens R, Rykx A, Vandeplassche L. A placebo-controlled trial of prucalopride for severe chronic constipation. N Engl J Med 2008; 358: 2344-54. (Among 620 adults with chronic idiopathic constipation treated with prucalopride [2 or 4 mg] vs placebo once daily for 12 weeks, response rates were 31% and 28% vs 12% and adverse events included diarrhea [13.5% and 18.6% vs 5.3%] and nausea [22% vs 8%], but there were no differences in changes in clinical test results among the different treatment groups). 18509121
Camilleri M, Beyens G, Kerstens R, Robinson P, Vandeplassche L. Safety assessment of prucalopride in elderly patients with constipation: a double-blind, placebo-controlled study. Neurogastroenterol Motil 2009; 21: 1256-e117. (Among 89 elderly nursing home residents treated with prucalopride [0.5, 1 and 2 mg] vs placebo once daily for 28 days, adverse events included diarrhea, abdominal pain but there were “no clinically relevant changes or dose-related effects in the clinical laboratory parameters”). 19751247
Camilleri M, Van Outryve MJ, Beyens G, Kerstens R, Robinson P, Vandeplassche L. Clinical trial: the efficacy of open-label prucalopride treatment in patients with chronic constipation - follow-up of patients from the pivotal studies. Aliment Pharmacol Ther 2010; 32: 1113-23. (Among 1455 patients with chronic idiopathic constipation enrolled in a continuation trial of prucalopride [2 or 4 mg daily], satisfaction with bowel function remained high [57% to 67%] and adverse events leading to discontinuation included headache, nausea, diarrhea and abdominal pain; no mention of ALT elevations or hepatotoxicity). 21039673
Sloots CE, Rykx A, Cools M, Kerstens R, De Pauw M. Efficacy and safety of prucalopride in patients with chronic noncancer pain suffering from opioid-induced constipation. Dig Dis Sci 2010; 55: 2912-21. (Among 196 patients with opioid induced constipation treated with prucalopride or placebo for 4 weeks, response rates were higher with prucalopride [2 mg 36%, 4 mg 40% vs placebo 23%] and “there were no clinically relevant differences between groups in…laboratory measures”). 20428949
Müller-Lissner S, Rykx A, Kerstens R, Vandeplassche L. A double-blind, placebo-controlled study of prucalopride in elderly patients with chronic constipation. Neurogastroenterol Motil 2010; 22: 991-8. (Among 300 elderly persons with chronic idiopathic constipation treated with prucalopride [1,2 or 4 mg] vs placebo daily for 4 weeks, clinical responses were more frequent with the higher doses of prucalopride and adverse events were typically headache and gastrointestinal complaints, while there were no clinically significant differences in laboratory assessments). 20529205
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to prokinetic agents or the 5-HT4 receptor agonists). 20949552
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Among 624,673 adverse event reports in children between 2000 and 2006 in the WHO VigiBase, 1% were hepatic, but no prokinetic agent or 5-HT4 receptor agonist was listed among the 41 most commonly implicated agents). 21039766
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 114: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to prokinetic agents or the 5-HT4 receptor agonists). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to prokinetic agents or 5-HT4 receptor agonists). 24552865
Mugie SM, Korczowski B, Bodi P, Green A, Kerstens R, Ausma J, Ruth M, et al. Prucalopride is no more effective than placebo for children with functional constipation. Gastroenterology 2014; 147: 1285-95. (Among 213 children with idiopathic constipation treated with prucalopride or placebo for 8 weeks, response rates were similar in both groups [17% vs 18%] as were adverse event rates [70% vs 61%], and changes in clinical chemistry results were minimal and similar in the two groups). 25239590
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, one case was attributed to metoclopramide, but none to other prokinetic agents). 25754159
Piessevaux H, Corazziari E, Rey E, Simren M, Wiechowska-Kozlowska A, Kerstens R, Cools M, et al. A randomized, double-blind, placebo-controlled trial to evaluate the efficacy, safety, and tolerability of long-term treatment with prucalopride. Neurogastroenterol Motil 2015; 27: 805-15. (Among 361 adults with chronic idiopathic constipation treated with prucalopride [2 mg daily] vs placebo for 24 weeks, clinical response rates were similar in both groups [25% vs 21%] as were adverse events [42% vs 42%]; there were no hepatic serious adverse events and no mention of ALT elevations or hepatotoxicity). 25808103
Yiannakou Y, Piessevaux H, Bouchoucha M, Schiefke I, Filip R, Gabalec L, Dina I, et al. A randomized, double-blind, placebo-controlled, phase 3 trial to evaluate the efficacy, safety, and tolerability of prucalopride in men with chronic constipation. Am J Gastroenterol 2015; 110: 741-8. (Among 374 men with chronic idiopathic constipation treated with prucalopride or placebo, clinical responses were more frequent with prucalopride [38% vs 18%] as were adverse events [42% vs 34%], and mean changes from baseline in clinical laboratory results were “generally small” and were not considered clinically relevant). 25869393
Camilleri M, Piessevaux H, Yiannakou Y, Tack J, Kerstens R, Quigley EM, Ke M, et al. Efficacy and safety of prucalopride in chronic constipation: an integrated analysis of six randomized, controlled clinical trials. Dig Dis Sci 2016; 61: 2357-72. (Pooled analysis of 7 placebo controlled trials of prucalopride in chronic idiopathic constipation identified 2484 patients among whom response rates were higher with prucalopride [28% vs 13%] and adverse events [mean duration of exposure=87 days] more frequent with prucalopride [63% vs 53%], but were mostly mild and none were fatal, while rates of abnormalities of laboratory tests were low and similar in both groups). 27056037

## OTHER REFERENCE LINKS

1. Recent References on Prucalopride: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Prucalopride/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Prucalopride: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Prucalopride)